# Telaprevir

## OVERVIEW

### Introduction

Telaprevir is an oral, direct acting hepatitis C virus (HCV) protease inhibitor that was used in combination with other antiviral agents in the treatment of chronic hepatitis C, genotype 1. Approved for use in the United States in 2012, it was withdrawn in 2015 when regimens of all oral direct acting agents with superior efficacy and better tolerance became available. Telaprevir was not linked to instances of acute liver injury during therapy, but was linked to cases of severe cutaneous reactions such as DRESS and Stevens Johnson syndrome which were associated with mild hepatic injury. In addition, when combined with peginterferon and ribavirin, telaprevir was associated with cases of hepatic decompensation in patients with preexisting cirrhosis.

### Background

The hepatitis C virus is a small RNA virus that is a major cause of chronic hepatitis, cirrhosis and hepatocellular carcinoma in the United States as well as worldwide. Various approaches to antiviral therapy of chronic hepatitis C have been developed, starting in the 1980s with interferon alfa which was replaced in the 1990s by long acting forms of interferon (peginterferon), to which was added the oral nucleoside analogue, ribavirin. Between 2010 and 2015, several potent oral, direct acting anti-HCV agents were developed and combinations of these found to have marked activity against the virus, allowing for highly effective therapy without use of interferon and with treatment courses of 8 to 12 weeks only. These direct acting agents included HCV protease (NS3/4) inhibitors, structural replication complex (NS5A) inhibitors and the HCV RNA polymerase (NS5B) inhibitors. The HCV proteases that have been developed are polypeptide-like molecules, modified amino acids that that resemble the specific amino acid sequence that the viral protease cleaves and act as competitive inhibitors of the protease enzyme. The first HCV protease inhibitors (all having the suffix: -previrs) approved for use in the United States were boceprevir [2012: Victrelis] and telaprevir [2012: Incevek], both used in combination with peginterferon and ribavirin. Subsequently, five more HCV protease inhibitors were approved for use in the United States: simeprevir [2013, Olysio], paritaprevir [2014, Viekira Pak], grazoprevir [2016, Zepatier], glecaprevir [2017: Mavyret], and Voxilaprevir [2017: Vosevi].

Telaprevir (tel a' pre vir), like other HCV protease inhibitors, blocks the activity of the viral encoded protease (HCV nonstructural [NS] region 3/4) that is essential in the posttranslational modification of the viral polypeptide that is cleaved into a series of structural and nonstructural (enzyme) regions. When used by itself, telaprevir results in rapid inhibition of HCV RNA levels, but resistance develops rapidly in a high proportion of patients. When combined with peginterferon and ribavirin, it was shown to provide a sustained inhibition of HCV RNA with a low rate of antiviral resistance. Triple therapy with telaprevir, peginterferon and ribavirin, when given for 24 to 48 weeks, increased the sustained virological response (SVR) rate from 40% to 50% (peginterferon and ribavirin alone) to 70% to 85% in patients with genotype 1. Telaprevir was approved for use in the United States in 2011 for patients with chronic hepatitis C, genotype 1, to be used in combination with peginterferon and ribavirin. Since that time, telaprevir has been replaced by more potent and better tolerated oral antiviral agents that can be given in combination without peginterferon. For these reasons, telaprevir was withdrawn by the sponsor in 2015. Telaprevir was previously available under the brand name Incivek (formerly VX950) as tablets of 375 mg. The recommended dose was 750 mg three times daily for the first 12 of the 24 or 48 weeks of combination therapy. The side effects of telaprevir were difficult to separate from those of peginterferon and ribavirin, but the triple therapy was associated with a higher rate of many side effects, including anemia, fatigue, itching, rash, anal pruritus and burning and gastrointestinal upset. Rash was particularly common with telaprevir therapy occurring in at least half of patients and occasionally being associated with DRESS or Stevens Johnson syndrome.

### Hepatotoxicity

In large randomized controlled trials, triple therapy with telaprevir, peginterferon and ribavirin was associated with a high rate of adverse events that often required dose adjustments and led to early discontinuation in 5% to 20% of patients. However, serum ALT elevations and clinically apparent liver injury were not generally mentioned as adverse events of therapy. Telaprevir, however, was associated with a high rate of rash, which was sometimes associated with features of hypersensitivity, including rare instances of DRESS and Stevens Johnson syndrome. These severe cutaneous reactions are often accompanied by laboratory evidence of hepatic injury (ALT and alkaline phosphatase elevations). In reported cases, however, the rash and other features of hypersensitivity typically overshadowed the hepatic injury and none were reported to be associated with jaundice.

Another rare but severe hepatic complications of telaprevir therapy occurs in patients with advanced fibrosis or cirrhosis, among whom de novo, seemingly spontaneous hepatic decompensation occurred in a proportion of treated subjects. Decompensation was particularly common in patients with advanced fibrosis or cirrhosis with a previous history of decompensation. The cause of the decompensation was not clear and the separate role of telaprevir in contrast to peginterferon and ribavirin could not be defined. Nevertheless, in postmarketing studies of triple therapy of chronic hepatitis C with cirrhosis, decompensation was reported in 2% to 8% of patients, and deaths from hepatic failure in 1% to 3%.

Likelihood score for the combination of telaprevir, peginterferon and ribavirin: B (likely cause of liver injury and hepatic decompensation in patients with preexisting cirrhosis or advanced fibrosis).

### Mechanism of Injury

The mechanism by which telaprevir might cause liver injury is not known. It is metabolized in the liver largely via the cytochrome P450 system, predominantly CYP 3A4, and liver injury may be due to production of a toxic or immunogenic metabolite. It is also a substrate of P-glycoprotein (P-gp). Telaprevir is also susceptible to multiple drug-drug interactions and can cause increases in serum concentrations of drugs that depend upon CYP 3A4 metabolism or P-gp. The other adverse effects of telaprevir, particularly when combined with peginterferon and ribavirin, may predispose to events that might lead to hepatic decompensation in a susceptible patient. Triple therapy using telaprevir (as well as with boceprevir and simeprevir) can cause anemia, neutropenia, thrombocytopenia, severe infections, gastrointestinal upset, dehydration and rash, all of which might help precipitate hepatic decompensation in a patient with underlying cirrhosis or advanced fibrosis.

### Outcome and Management

Rash was common with telaprevir therapy and several cutaneous reactions were occasionally accompanied by evidence of hepatic injury. There is no reason to suspect cross sensitivity to the cutaneous hypersensitivity between telaprevir and other oral antivirals active against hepatitis C. Triple therapy using telaprevir is no longer used, but it was considered inadvisable in patients with preexisting cirrhosis, particularly those with a prior history of hepatic decompensation. A similar high rate of decompensation of preexisting cirrhosis was reported with triple therapy using boceprevir and simeprevir, two other HCV protease inhibitors. In fact, hepatic decompensation was also a reported complication of all-oral antiviral therapy of hepatitis C, although the rates reported with non-interferon and non-ribavirin containing regimens were quite low (<1%).

Drug Class: Antiviral Agents, Hepatitis C Agents, HCV Protease Inhibitors

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Telaprevir – Incivek®

DRUG CLASS

Hepatitis C Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Telaprevir)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Telaprevir | 402957-28-2 | C36-H53-N7-O6

## ANNOTATED BIBLIOGRAPHY

References updated: 26 January 2022

Abbreviation used: HCV, hepatitis C virus; HIV, human immunodeficiency virus; SVR, sustained virological response.

Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013. (Multi-authored textbook of hepatotoxicity published in 2013 does not discuss oral, direct acting antiviral agents used to treat hepatitis C).
Kim JL, Morgenstern KA, Lin C, Fox T, Dwyer MD, Landro JA, Chambers SP, et al. (1996). Crystal structure of the hepatitis C virus NS3 protease domain complexed with a synthetic NS4A cofactor peptide. Cell. (Report of the crystal structure of the NS3/4 region of HCV with detailed description of the active serine protease catalytic site, the target for subsequent development of specific inhibitors of the HCV protease).
Lawitz E, Rodriguez-Torres M, Muir AJ, Kieffer TL, McNair L, Khunvichai A, McHutchison JG. (2008). Antiviral effects and safety of telaprevir, peginterferon alfa-2a, and ribavirin for 28 days in hepatitis C patients. J Hepatol. (Among 12 patients treated with telaprevir, peginterferon and ribavirin for 4 weeks, all became HCV RNA negative by 28 days, and all 8 patients who continued peginterferon and ribavirin thereafter for up to 48 weeks had an SVR; during telaprevir therapy, 4 patients developed rash; no mention of de novo ALT elevations).
Hézode C, Forestier N, Dusheiko G, Ferenci P, Pol S, Goeser T, Bronowicki JP, et al., PROVE2 Study Team. (2009). Telaprevir and peginterferon with or without ribavirin for chronic HCV infection. N Engl J Med. (Among 334 patients with previously untreated chronic hepatitis C, genotype 1, who received various regimens of peginterferon, ribavirin and telaprevir, SVR rates were higher with telaprevir, but were also increased by ribavirin; common adverse events included rash and pruritus; no mention of hepatic complications or de novo ALT elevations).
McHutchison JG, Everson GT, Gordon SC, Jacobson IM, Sulkowski M, Kauffman R, McNair L, et al., PROVE1 Study Team. (2009). Telaprevir with peginterferon and ribavirin for chronic HCV genotype 1 infection. N Engl J Med. (Among 240 patients with chronic hepatitis C, genotype 1, who received various regimens of telaprevir, peginterferon and ribavirin, SVR rates were higher with telaprevir as were adverse events of rash, pruritus, nausea and diarrhea, severe rash occurring in 5-9% of patients; no mention of ALT elevations or hepatic adverse events).
McHutchison JG, Manns MP, Muir AJ, Terrault NA, Jacobson IM, Afdhal NH, Heathcote EJ, et al., PROVE3 Study Team. (2010). Telaprevir for previously treated chronic HCV infection. N Engl J Med. (Among 453 patients with previously treated chronic hepatitis C, genotype 1, treated with one of 4 regimens of peginterferon, ribavirin and telaprevir, SVR rates were higher with telaprevir [24-51% vs 14%] as were serious adverse events [17-24% vs 11%], rash occurring in at least half of patients on telaprevir, usually within 1-4 weeks of starting and requiring discontinuation in 5%; no mention of ALT elevations or liver related adverse events).
Montaudié H, Passeron T, Cardot-Leccia N, Sebbag N, Lacour JP. (2010). Drug rash with eosinophilia and systemic symptoms due to telaprevir. Dermatology. (57 year old woman with chronic hepatitis C developed rash, fever, fatigue and lymphadenopathy 6 weeks after starting telaprevir with peginterferon and ribavirin [ALT 61 U/L, eosinophils 2,700/µL, HCV RNA negative, bilirubin and Alk P not given], resolving with prednisone therapy, but with subsequent HCV relapse; had previously received peginterferon and ribavirin without rash).
Sherman KE, Flamm SL, Afdhal NH, Nelson DR, Sulkowski MS, Everson GT, Fried MW, et al., ILLUMINATE Study Team. (2011). Response-guided telaprevir combination treatment for hepatitis C virus infection. N Engl J Med. (Among 540 previously untreated patients with chronic hepatitis C, genotype 1, treated with telaprevir [12 weeks] and ribavirin and peginterferon [for 12, 24 or 48 weeks], the overall rate of SVR was 72%, rash 37% and any serious adverse events 9%; no mention of ALT elevations or liver related adverse events).
Zeuzem S, Andreone P, Pol S, Lawitz E, Diago M, Roberts S, Focaccia R, et al., REALIZE Study Team. (2011). Telaprevir for retreatment of HCV infection. N Engl J Med. (Among 663 patients with previously treated chronic hepatitis C, genotype 1, who were treated with various regimens of telaprevir [12 weeks] with or without 48 weeks of peginterferon and ribavirin, SVR rates were higher with telaprevir [64-66% vs 17%] as were side effects of fatigue, gastrointestinal upset, pruritus, rash, anemia and neutropenia; no mention of liver related adverse events).
Jacobson IM, McHutchison JG, Dusheiko G, Di Bisceglie AM, Reddy KR, Bzowej NH, Marcellin P, et al., ADVANCE Study Team. (2011). Telaprevir for previously untreated chronic hepatitis C virus infection. N Engl J Med. (Among 1088 patients with previously untreated chronic hepatitis C, genotype 1, who were treated with peginterferon and ribavirin with vs without 12 weeks of telaprevir, SVR rates were higher with telaprevir [69-75% vs 44%], but serious adverse events rates were similar [9% vs 7%]; one case of Stevens Johnson syndrome and one liver disease death occurred in telaprevir groups, but few details were provided).
(2011). Telaprevir (Incivek) and boceprevir (Victrelis) for chronic hepatitis C. Med Lett Drugs Ther. (Concise review of the efficacy, safety and costs of boceprevir and telaprevir, shortly after their approval for use as a part of triple therapy of chronic hepatitis C, genotype 1, in the US, mentions side effects of rash, anemia, fatigue, pruritus, nausea and anorectal pruritus and burning, but not ALT elevations or clinically apparent liver injury).
Cacoub P, Bourlière M, Lübbe J, Dupin N, Buggisch P, Dusheiko G, Hézode C, et al. (2012). Dermatological side effects of hepatitis C and its treatment: patient management in the era of direct-acting antivirals. J Hepatol. (Review of the clinical features and management of dermatologic side effects of triple therapy with telaprevir, during which rash arises in half of patients, usually during the first 1-12 weeks, typically mild-to-moderate in severity, but requiring discontinuation in 6% of patients, and more severe examples reported have include suspected Stevens Johnson syndrome in 3 and DRESS in 11 patients).
Hayashi N, Okanoue T, Tsubouchi H, Toyota J, Chayama K, Kumada H. (2012). Efficacy and safety of telaprevir, a new protease inhibitor, for difficult-to-treat patients with genotype 1 chronic hepatitis C. J Viral Hepat. (Among 141 previously treated Japanese patients with chronic hepatitis C, genotype 1, treated with telaprevir [12 weeks] with ribavirin and peginterferon [24 weeks], the overall SVR rate was 76% and serious adverse event rate 11%, most troublesome being anemia and rash; no mention of ALT elevations or hepatotoxicity).
Sulkowski MS, Sherman KE, Dieterich DT, Bsharat M, Mahnke L, Rockstroh JK, Gharakhanian S, et al. (2013). Combination therapy with telaprevir for chronic hepatitis C virus genotype 1 infection in patients with HIV: a randomized trial. Ann Intern Med. (Among 62 patients with chronic hepatitis C, genotype 1, and HIV coinfection treated with telaprevir or placebo [12 weeks] and peginterferon and ribavirin [48 weeks], SVR rates were higher with telaprevir [74% vs 45%] as were serious adverse events [5% vs 0 in first 12 weeks]; no mention of ALT elevations or hepatic adverse events).
Hézode C, Fontaine H, Dorival C, Larrey D, Zoulim F, Canva V, de Ledinghen V, et al., CUPIC Study Group. (2013). Triple therapy in treatment-experienced patients with HCV-cirrhosis in a multicentre cohort of the French Early Access Programme (ANRS CO20-CUPIC) - NCT01514890. J Hepatol. (Among 497 patients with chronic hepatitis C, genotype 1, and cirrhosis treated in a French early access program with 48 weeks of peginterferon and ribavirin with either boceprevir or telaprevir, serious adverse events occurred in 197 patients [40%], hepatic decompensation in 12 [2.4%], severe infection in 24 [4.8%], and 6 patients died [1.5%], the serious complications typically arising in the first 12 weeks of therapy).
Coilly A, Roche B, Dumortier J, Leroy V, Botta-Fridlund D, Radenne S, Pageaux GP, et al. (2014). Safety and efficacy of protease inhibitors to treat hepatitis C after liver transplantation: a multicenter experience. J Hepatol. (Among 37 patients with severe recurrent chronic hepatitis C, genotype 1, after liver transplantation who were treated with peginterferon, ribavirin and either boceprevir or telaprevir for up to 48 weeks, 6 [16%] had an SVR, 10 [27%] a severe infection and 3 [8%] died).
Park C, Jiang S, Lawson KA. (2014). Efficacy and safety of telaprevir and boceprevir in patients with hepatitis C genotype 1: a meta-analysis. J Clin Pharm Ther. (Analysis of efficacy and safety of telaprevir and boceprevir in triple therapy in 10 controlled trials of 4421 patients with chronic hepatitis C, genotype 1; serious adverse events were higher with triple therapy than with peginterferon and ribavirin alone).
Colombo M, Fernández I, Abdurakhmanov D, Ferreira PA, Strasser SI, Urbanek P, Moreno C, et al. (2014). Safety and on-treatment efficacy of telaprevir: the early access programme for patients with advanced hepatitis C. Gut. (Among 1587 patients with chronic hepatitis C, genotype 1, and cirrhosis treated with telaprevir [12 weeks] combined with peginterferon and ribavirin [for 24 or 48 weeks], serious adverse events were common during the first 16 weeks leading to drug discontinuation in 12% of patients and death in 7 patients; rash developed in 13% of patients, led to drug discontinuation in 5% and was compatible with Stevens Johnson syndrome in one).
Hézode C, Fontaine H, Dorival C, Zoulim F, Larrey D, Canva V, De Ledinghen V, et al., CUPIC Study Group. (2014). Effectiveness of telaprevir or boceprevir in treatment-experienced patients with HCV genotype 1 infection and cirrhosis. Gastroenterology. (Among 511 patients with cirrhosis and chronic hepatitis C, genotype 1, and cirrhosis treated with triple therapy using telaprevir or boceprevir for 48 weeks, 91 [18%] patients had an SVR, severe adverse events occurred in 50%, including liver decompensation in 43 [8%], severe infections in 28 [5.5%] and death in 11 [2.2%]).
Burton JR, O'Leary JG, Verna EC, Saxena V, Dodge JL, Stravitz RT, Levitsky J, et al. (2014). A US multicenter study of hepatitis C treatment of liver transplant recipients with protease-inhibitor triple therapy. J Hepatol. (Among 81 patients with recurrent hepatitis C, genotype 1, after liver transplant who were treated with triple therapy using peginterferon, ribavirin and either boceprevir or telaprevir, the overall SVR rate was 63%, the serious adverse event rate was not reported, but 27% required hospitalization, 15% early drug discontinuation and 7 patients [9%] died of liver failure).
Gordon SC, Muir AJ, Lim JK, Pearlman B, Argo CK, Ramani A, Maliakkal B, et al., HCV-TARGET study group. (2015). Safety profile of boceprevir and telaprevir in chronic hepatitis C: real world experience from HCV-TARGET. J Hepatol. (Among 2084 patients with chronic hepatitis C, genotype 1, treated in clinical practice with peginterferon, ribavirin and either boceprevir or telaprevir for up to 48 weeks, the overall SVR rate was 52%, serious adverse event rate 12% while hepatic decompensation occurred in 3% and 5 patients [0.25%] died, all from hepatic failure; rash was a common side effect [63% with telaprevir and 34% with boceprevir] and was graded as serious in 8 patients [0.5%], 2 [0.1%] with DRESS).
Miailhes P, Gilbert C, Lacombe K, Arends JE, Puoti M, Rockstroh JK, Sogni P, et al., ESCMID European Study Group on Viral Hepatitis. (2015). Triple therapy with boceprevir or telaprevir in a European cohort of cirrhotic HIV/HCV genotype 1-coinfected patients. Liver Int. (Among 59 patients with chronic hepatitis C, cirrhosis and HIV-coinfection treated with peginterferon, ribavirin and either boceprevir [n=12] or telaprevir [n=47], the SVR rate was 36% vs 57%, and adverse events included rash [46% vs 8%] and hepatic decompensation [1 each]).
Verna EC, Saxena V, Burton JR, O'Leary JG, Dodge JL, Stravitz RT, Levitsky J, et al. (2015). CRUSH-C Consortium. Telaprevir- and boceprevir-based triple therapy for hepatitis C in liver transplant recipients with advanced recurrent disease: a multicenter study. Transplantation. (Among 54 patients with advanced, recurrent chronic hepatitis C, genotype 1, after liver transplantation, who were treated with peginterferon, ribavirin and either boceprevir or telaprevir for up to 48 weeks, the SVR rate was 50%, but hepatic decompensation arose in 24% and 6 patients [11%] died).
Neukam K, Munteanu DI, Rivero-Juárez A, Lutz T, Fehr J, Mandorfer M, Bhagani S, et al. (2015). Boceprevir or telaprevir based triple therapy against chronic hepatitis C in HIV coinfection: real-life safety and efficacy. PLoS One. (Among 159 patients with chronic hepatitis C, genotype 1, treated in health care clinics in 5 European countries with peginterferon, ribavirin and either boceprevir or telaprevir for up to 48 weeks, the overall SVR rate was 63%, while 4 patients [2.5%] developed hepatic decompensation, one of whom died to hepatic failure).
Bailly F, Pradat P, Virlogeux V, Zoulim F. (2015). Antiviral therapy in patients with hepatitis C virus-induced cirrhosis. Dig Dis. (Review of the status of antiviral therapy of chronic hepatitis C with cirrhosis summarizing the high rate of adverse events including hepatic decompensation and death with peginterferon based regimens combined with boceprevir or telaprevir, and the more effective and better tolerated all-oral regimens).
Ferenci P, Kozbial K, Mandorfer M, Hofer H. (2015). HCV targeting of patients with cirrhosis. J Hepatol. (Review of the status of antiviral therapy of chronic hepatitis C with cirrhosis, suggests that genotype 1 infected patients should receive an all-oral regimen such as sofosbuvir with ledipasvir or daclatasvir or the triple combination of dasabuvir with ombitasvir and paritaprevir, the major issues being duration of therapy and the role of ribavirin).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 12 were attributed to antiviral agents, but all were antiretroviral agents and no case was attributed to the oral direct acting agents used to treat hepatitis C).
European Association for Study of Liver. (2015). EASL Recommendations on Treatment of Hepatitis C 2015. J Hepatol. (Guidelines for the antiviral therapy of chronic hepatitis C from the European liver disease research and academic society).
AASLD/IDSA HCV Guidance Panel. (2015). Hepatitis C guidance: AASLD-IDSA recommendations for testing, managing, and treating adults infected with hepatitis C virus. Hepatology. (Guidelines for the antiviral therapy of chronic hepatitis C from the US liver and infectious diseases research and academic societies).
Carrascosa R, Capusan TM, Llamas-Velasco M, García-Buey L, Gordillo C, Sánchez-Pérez J. (2016). High frequency of severe telaprevir-associated skin eruptions in clinical practice. Acta Derm Venereol. (Among 60 patients with chronic hepatitis C, genotype 1, treated with telaprevir, peginterferon and ribavirin, 29 developed skin eruptions usually within 5-12 weeks, one with erythema multiforme and one DRESS syndrome, 6 episodes led to early discontinuation; no mention of ALT elevations or hepatic injury).
Salmerón J, Vinaixa C, Berenguer R, Pascasio JM, Sánchez Ruano JJ, Serra MÁ, Gila A, et al., Alhambra Spanish Study Group. (2015). Effectiveness and safety of first-generation protease inhibitors in clinical practice: Hepatitis C virus patients with advanced fibrosis. World J Gastroenterol. (Among 1057 patients with chronic hepatitis C who were treated with peginterferon, ribavirin and either telaprevir or boceprevir at 38 Spanish hospitals, 635 [60%] had an SVR, and adverse events were largely hematologic; no mention of ALT elevations or hepatotoxicity).
Lepida A, Colombo M, Fernandez I, Abdurakhmanov D, Ferreira PA, Strasser SI, Urbanek P, et al. (2015). Final results of the telaprevir access program: FibroScan values predict safety and efficacy in hepatitis C patients with advanced fibrosis or cirrhosis. PLoS One. (Among 1722 patients with chronic hepatitis C, genotype 1, and advanced fibrosis who were treated with peginterferon, ribavirin and telaprevir, 1139 [64%] had an SVR and common adverse events were anemia [56%], rash [30%] and pruritus [16%]; no mention of ALT elevations or hepatotoxicity).
Coilly A, Dumortier J, Botta-Fridlund D, Latournerie M, Leroy V, Pageaux GP, Agostini H, et al. (2015). Multicenter experience with boceprevir or telaprevir to treat hepatitis C recurrence after liver transplantation: when present becomes past, what lessons for future?. PLoS One. (Among 81 patients with recurrent hepatitis C after liver transplantation who were treated with peginterferon, ribavirin and either telaprevir or boceprevir, 38 [47%] had an SVR, 22 [27%] a serious adverse event, 10 [12%] acute rejection, and 4 [5%] died, largely of infectious complications; no mention of ALT elevations or hepatotoxicity).
Janczewska E, Flisiak R, Zarebska-Michaluk D, Kozielewicz D, Berak H, Dobracka B, Librant-Suska M, et al. (2015). Effect of peginterferon or ribavirin dosing on efficacy of therapy with telaprevir in treatment-experienced patients with chronic hepatitis C and advanced liver fibrosis: a multicenter cohort study. Medicine (Baltimore). (Among 211 treatment experienced patients with chronic hepatitis C, genotype 1, and advanced liver disease [68% with cirrhosis] treated with peginterferon, ribavirin and telaprevir, 118 [56%] had an SVR, 31 [15%] had a serious adverse reaction, and 4 died; but no death was attributed to treatment and there was no mention of ALT elevations or hepatotoxicity).
Kawaguchi Y, Iwane S, Kumagai T, Yanagita K, Yasutake T, Ide Y, Otsuka T, et al. (2015). Efficacy and safety of telaprevir, pegylated interferon α-2b and ribavirin triple therapy in Japanese patients infected with hepatitis C virus genotype 1b. Intern Med. (Among 106 Japanese patients with chronic hepatitis C, genotype 1b, treated with peginterferon, ribavirin and telaprevir for 24 weeks, 93 [88%] had a SVR, but adverse events were frequent including rash [28%], anemia [76%] and 31% discontinued telaprevir early; no mention of ALT elevations or hepatotoxicity).
Ueda Y, Ikegami T, Soyama A, Akamatsu N, Shinoda M, Ishiyama K, Honda M, et al. (2016). Simeprevir or telaprevir with peginterferon and ribavirin for recurrent hepatitis C after living donor liver transplantation: A Japanese multicenter experience. Hepatol Res. (Among 79 patients with chronic hepatitis C, genotype 1, after liver transplantation who were treated wtih peginterferon, ribavirin and either simeprevir [n=79] or telaprevir [n=36], the SVR rates were 56% vs 69%, serious adverse event rates 11% vs 25%, and immune mediated graft dysfunction occurred in 8% vs 11%).
Montes ML, Nelson M, Girard PM, Sasadeusz J, Horban A, Grinsztejn B, Zakharova N, et al. (2016). Telaprevir-based therapy in patients coinfected with chronic hepatitis C virus infection and HIV: INSIGHT study. J Antimicrob Chemother. (Among 162 patients with chronic hepatitis C and HIV infection treated with telaprevir, peginterferon and ribavirin, hyperbilirubinemia occurred in 37 patients which was attributable to atazanavir in 36, but there were no clinically relevant changes in other hepatic laboratory results).
Morisco F, Masarone M, Rosato V, Camera S, Granata R, Tartaglione MT, Coppola C, et al. (2016). Impact of telaprevir in HCV patients with cirrhosis and RVR: real-life data from boceprevir or telaprevir based "triple therapy" experience in Southern Italy. Rev Recent Clin Trials. (Among 103 Italian patients with cirrhosis due to HCV, genotype 1, treated with telaprevir or boceprevir with peginterferon and ribavirin, the SVR rate was 59% and serious adverse event rate 4.6%: no hepatic adverse events requiring discontinuation).
Kumada H, Suzuki F, Kamiya N, Orihashi M, Nakayasu Y, Yamada I. (2017). Efficacy and safety of telaprevir with pegylated interferon α-2a and ribavirin in Japanese patients. Hepatol Res. (Among 54 Japanese patients with chronic hepatitis C, genotype 1, treated with telaprevir, peginterferon and ribavirin, the SVR rate was 89% while adverse events were frequent and telaprevir was discontinued early in 23 patients, largely due to rash or anemia; no mention of ALT elevations or hepatotoxicity).
Forns X, Didier S, Mutimer D, Fagiuoli S, Navasa M, Agarwal K, Berenguer M, et al. (2016). Efficacy of telaprevir-based therapy in stable liver transplant patients with chronic genotype 1 hepatitis C. Ann Hepatol. (Among 74 patients with recurrence of HCV infection, genotype 1, after liver transplantation who were treated with telaprevir, peginterferon and ribavirin, the SVR rate was 72%, while tacrolimus and cyclosporin levels were often increased during telaprevir therapy requiring dose adjustment; common adverse events were anemia, pruritus, anorectal discomfort and rash; no mention of hepatotoxicity or hepatic decompensation).
Ascione A, Adinolfi LE, Amoroso P, Andriulli A, Armignacco O, Ascione T, Babudieri S, Cleo Study Group, et al. (2016). Boceprevir or telaprevir in hepatitis C virus chronic infection: The Italian real life experience. World J Hepatol. (Among 834 patients treated with telaprevir or boceprevir combined with peginterferon and ribavirin enrolled in a multicenter Italian database, the SVR rate was 63% but adverse events were frequent and led to early discontinuation in 15%, largely for rash [31%], anemia [23%], weakness [14%] and other reasons included ascites in 3 patients, but ALT elevations and hepatic dysfunction were not mentioned).
Flisiak R, Shiffman M, Arenas J, Cheinquer H, Nikitin I, Dong Y, Rana K, et al. (2016). A randomized study of peginterferon lambda-1a compared to peginterferon alfa-2a in combination with ribavirin and telaprevir in patients with genotype-1 chronic hepatitis C. PLoS One. (Among 617 patients with chronic hepatitis C, genotype 1, treated with peginterferon alfa or lambda combined with telaprevir and ribavirin, the SVR rate was 82% [alfa] vs 76% [lambda] and while overall adverse events were similar [97% vs 92%]; lambda therapy was associated with less cytopenia than alfa, but had a higher rate of jaundice [2.7% vs 1% ] and ALT elevations [7.3% vs 0.5%] and liver abnormalities led to dose reduction in 10%).
Iketani R, Ide K, Yamada H, Kawasaki Y, Masaki N. (2017). The safety profile of telaprevir-based triple therapy in clinical practice: a retrospective cohort study. Biol Pharm Bull. (Among 4619 patients treated for chronic hepatitis C In a nationwide Japanese database from 2009-2015, dropout rates were higher with peginterferon and ribavirin alone than with telaprevir triple therapy [23% vs 13%]; reasons for stopping telaprevir included fatigue [26%], anorexia [23%], anemia [16%], psychoneuroses [11%], retinopathy [6.1%], but no mention of hepatic adverse events).
Mangia A, Foster GR, Berg CP, Curescu M, Ledinghen V, Habersetzer F, Manolakopoulos S, et al. (2017). PegBase Group Investigators. Efficacy and safety profile of boceprevir-or telaprevir-based triple therapy or dual peginterferon alfa-2a or alfa-2b plus ribavirin therapy in chronic hepatitis C: the real-world PegBase observational study. Ann Gastroenterol. (Among 4100 patients with chronic hepatitis C, genotype 1, enrolled in an international database and treated with triple therapy of peginterferon [alfa-2a or alfa-2b], ribavirin, and either boceprevir or telaprevir, SVR rates ranged from 57% to 65% and were lower in those with cirrhosis [41% vs 66%], while serious adverse events included hepatic failure [n=4: 0.1%, 1.1% of cirrhotics], serious infections [45: 1.1%] and death [11: 0.2%]).
Callefi LA, Villela-Nogueira CA, de Barros Tenore S, Carnaúba-Júnior D, Coelho HSM, Pinto PTA, Nabuco LC, et al. (2017). Effectiveness and safety of first-generation protease inhibitors in real-world patients with hepatitis C virus genotype 1 infection in Brazil: a multicenter study. Clinics (Sao Paulo). (Among 715 Brazilian patients with chronic hepatitis C treated at 15 medical centers with peginterferon, ribavirin and either boceprevir [n=158] or telaprevir [n=557], the SVR rate was 57%, those with cirrhosis having a lower SVR [47% vs 71%] and higher severe adverse event rate [51% vs 35%], which included hepatic decompensation in 18 patients [4% of total, 6.6% of cirrhotics]).
Fernández-Crehuet P, Ruiz-Villaverde R. (2018). DRESS syndrome induced by telaprevir: a potentially fatal adverse event in chronic hepatitis C therapy. Cutis. (58 year old woman developed severe generalized rash 2 months after the addition of telaprevir to peginterferon and ribavirin therapy of chronic hepatitis C, with fever, eosinophilia, facial edema, mild ALT elevations [60 U/L] and skin biopsy compatible with DRESS, responding rapidly to corticosteroid therapy).
Cengiz FP, Su O, Emiroglu N, Biyik Ozkaya D, Bahali AG, Onsun N. (2019). A rare and severe cutaneous adverse effect of telaprevir: drug rash with eosinophilia and systemic symptoms. G Ital Dermatol Venereol. (64 year old man with chronic hepatitis C developed rash, fever, facial edema, lymphadenopathy and liver test elevations [AST 36 U/L, GGT 158 U/L, bilirubin 1.8 mg/dL], responding rapidly to corticosteroid therapy).
Baker JD, Uhrich RL, Kraemer GC, Love JE, Kraemer BC. (2021). A drug repurposing screen identifies hepatitis C antivirals as inhibitors of the SARS-CoV2 main protease. PLoS One. (High throughput screening of 6070 medications for activity against SARS-CoV2 in cell culture identified 8 agents with potent activity [IC50 less than 50 µM] including telaprevir and boceprevir).

## OTHER REFERENCE LINKS

1 Recent References on Telaprevir: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Telaprevir/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Telaprevir: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Telaprevir)